# Givosiran

## OVERVIEW

### Introduction

Givosiran is synthetic small interfering RNA (siRNA) molecule directed against 5-aminolevulinic acid synthase that is used to treat acute hepatic porphyria. Givosiran has been linked to mild-to-moderate ALT elevations during therapy, but has not been linked to instances of idiosyncratic acute liver injury with symptoms and jaundice.

### Background

Givosiran (giv” oh sir’ an) is a synthetic double stranded, small interfering RNA (siRNA) directed against 5-aminolevulinic acid synthase 1, which results in decreases in serum delta aminolevulinic acid (ALA) and porphobilinogen (PBG), intermediates in porphyrin metabolism which accumulate in patients with acute hepatic porphyrias and are believed to cause the neurologic and visceral symptoms of acute attacks. The siRNA molecule is covalently linked to three N-acetylgalactosamine residues which directs it to specific receptors found largely on hepatocytes. Once taken up by the hepatocyte, the siRNA is cleaved into smaller fragments and separated into single strands that bind and silence the mRNA of ALA synthase. In animal models, givosiran reduced ALA synthase mRNA levels in liver that was accompanied by a corresponding decline in urine and plasma ALA and PBG. In placebo controlled trials of givosiran in patients with recurring acute attacks, single infusions of givosiran resulted in dose related reductions in urinary ALA and PBG levels and, with monthly injections, annualized rates of attacks were reduced by 75% to 90%. Givosiran was approved for use in the United States for adults with acute hepatic porphyria in 2019. Current indications are limited to adults. Givosiran is available in solution in single dose vials of 189 mg/mL under the brand name Givlaari. The recommended regimen is 2.5 mg per kg body weight once monthly by subcutaneous injection. Givosiran is generally well tolerated but side effects can include nausea, injection site reactions, rash, fatigue and creatinine and serum aminotransferase elevations. Less common, but more severe side effects include severe injection reactions, anaphylaxis and recall reactions. In registration studies, immunogenicity was uncommon; only 1% of givosiran treated patients developed anti-drug antibodies.

### Hepatotoxicity

The acute hepatic porphyrias are rare, and the pivotal trials of givosiran were conducted in rather small numbers of patients, so the full spectrum of hepatotoxicity may not be fully known. Nevertheless, in the registration controlled trials, serum aminotransferase elevations arose in 13% of givosiran- versus 2% of placebo-recipients, but rose to levels above 5 times the upper limit of normal only rarely. One patient was reported as discontinuing givosiran therapy because of aminotransferase elevations, but no patient developed concurrent elevations in serum bilirubin or symptoms suggestive of hepatitis. Thus, givosiran has not been linked to instances of acute hepatitis or jaundice, but it has had limited clinical use.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from the givosiran and other siRNA therapeutics is unknown. One possibility is that suppression of 5-aminolevulinic acid synthase may cause cell damage in some hepatocytes. The mRNA suppression appears to lower but not completely eliminate enzyme activity, but individual hepatocytes may vary in the sensitivity to the enzyme inhibition and effects of its loss. Givosiran is metabolized intracellularly by nucleases and is not a substrate of cytochrome P450 enzymes. On the other hand, the chronic inhibition of ALA synthase can result in decreases in CYP 1A2 and 2D6 synthesis and lead to supra-therapeutic or toxic levels of drugs that are metabolized by these enzymes.

### Outcome and Management

The liver injury associated with givosiran therapy has invariably been mild, not associated with jaundice and rapidly resolving often without discontinuation or even dose adjustment. In prelicensure clinical trials, subjects received hemin therapy for acute attacks without evidence of liver injury, and there is no reason to suspect cross reactivity of hepatic injury with other therapies of acute porphyria. Monitoring of liver tests during therapy is recommended during givosiran therapy as well as interruption or discontinuation for significant elevations in serum aminotransferases.

Drug Class: Genetic Disorder Agents

Other Therapeutic siRNA and Antisense Agents: Eteplirsen, Golodirsen, Patisiran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Givosiran – Givlaari®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=167e663c-11e1-497b-a3fc-951d65d58eaa)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Givosiran | 1639325-43-1 | C78-H139-N11-O30

## ANNOTATED BIBLIOGRAPHY

References updated: 27 February 2020

Abbreviations: ALA, aminolevulinic acid; ALAS, aminolevulinic acid synthetase; PBG, porphobilinogen; siRNA, small interfering RNA.

Yasuda M, Gan L, Chen B, Kadirvel S, Yu C, Phillips JD, New MI, et al. (2014). RNAi-mediated silencing of hepatic Alas1 effectively prevents and treats the induced acute attacks in acute intermittent porphyria mice. Proc Natl Acad Sci U S A. (Screening of multiple small interfering RNAs [siRNA] for activity in suppressing aminolevulinic acid synthetase [ALAS] in cell culture identified several with potent activity which were formulated into lipid nanoparticles and shown to lower ALAS activity and decrease serum levels of aminolevulinic acid (ALA) and porphobilinogen (PBG) in mice and to protect against acute attacks of porphyria in mouse models of the disease).
Bonkovsky HL, Maddukuri VC, Yazici C, Anderson KE, Bissell DM, Bloomer JR, Phillips JD, et al. (2014). Acute porphyrias in the USA: features of 108 subjects from porphyrias consortium. Am J Med. (Among 108 subjects with acute porphyria enrolled in a U.S. prospective clinical cohort study, 90 had acute intermittent porphyria, 9 hereditary coproporphyria and 9 variegate porphyria; most were women [81%], non-Hispanic and white, and delay in diagnosis after onset of symptoms was common [mean delay=15 years]).
Bissell DM, Lai JC, Meister RK, Blanc PD. (2015). Role of delta-aminolevulinic acid in the symptoms of acute porphyria. Am J Med. (32 year old woman using several Ayurvedic medications developed recurrent abdominal pain and had elevations in serum ALA but not PBG, subsequent testing demonstrating lead poisoning and symptoms improving with hemin infusions but ultimately resolving after chelation of excess lead; these results suggest that ALA rather than PBG is the cause of neurologic and visceral symptoms in acute hepatic porphyria).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to siRNA therapies or medications for porphyria).
Sardh E, Harper P, Balwani M, Stein P, Rees D, Bissell DM, Desnick R, et al. (2019). Phase 1 Trial of an RNA interference therapy for acute intermittent porphyria. N Engl J Med. (A phase 1 trial of ascending, single doses of givosiran followed by studies of the two optimal doses vs placebo either once monthly or quarterly in 40 patients with acute intermittent porphyria demonstrated rapid and marked declines in urinary ALA and PBG levels and decreases in annualized acute attack rates of 75-90%; there were no liver related severe adverse events and “no clinically significant changes in laboratory measures”).
Setten RL, Rossi JJ, Han SP. (2019). The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]).
Chen B, Whatley S, Badminton M, Aarsand AK, Anderson KE, Bissell DM, Bonkovsky HL, et al., International Porphyria Molecular Diagnostic Collaborative. (2019). an evidence-based database of verified pathogenic and benign variants for the porphyrias. Genet Med. (Announcement of a collaborative international effort to define phenotypes and genotypes of the 4 acute hepatic porphyrias, 3 being autosomal dominant [acute intermittent porphyria, hereditary coproporphyria and variegate porphyria] and 1 autosomal recessive, the genetic variation and clinical expression of each being highly variable).
Gouya L, Ventura P, Balwani M, Bissell DM, Rees DC, Stölzel U, Phillips JD, et al. (2019). EXPLORE: A prospective, multinational, natural history study of patients with acute hepatic porphyria with recurrent attacks. Hepatology. (Among 112 patients with acute hepatic porphyria and recurrent attacks followed for at least 6 months, 98 [88%] had a total of 483 attacks, 371 [77%] requiring hemin therapy and, compared to baseline, urinary levels of ALA, PBG and ALAS mRNA increased during acute attacks).
Naik H, Overbey JR, Montgomery GH, Winkel G, Balwani M, Anderson KE, Bissell DM, et al. (2020). Evaluating the patient-reported outcomes measurement information system scales in acute intermittent porphyria. Genet Med. (Analysis of symptom scores in a cohort of 259 patients [75% with symptoms] with acute intermittent porphyria).
Scott LJ. (2020). Givosiran: first approval. Drugs. (Review of the mechanism of action, history of development, clinical efficacy and safety of givosiran shortly after its approval for use in acute hepatic porphyria in the US and Europe mentions that in the registration trial, the median composite annualized attack rate at 6 months was decreased by 90% and adverse events in treated vs control subjects included nausea [27% vs 11%], injection site reactions [25% vs 0%], rash [17% vs 4%], creatinine increase [15% vs 4%], aminotransferase elevations [13% vs 2%] and fatigue [10% vs 4%]).
FDA. Givosiran. Multi-Disciplinary Review and Evaluation. 2019. Available at: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212194Orig1s000MultidisciplineR.pdf (The FDA clinical review of givosiran for efficacy and safety reported ALT elevations above 3 times ULN arose in 6 of 48 [13%] givosiran treated vs 1 of 46 [2%] controls, one patient discontinuing therapy because of enzyme elevations after 3 doses [ALT 172 U/L, AST 95 U/L] which reportedly resolved rapidly upon stopping).

## OTHER REFERENCE LINKS

1 Recent References on Givosiran: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Givosiran/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))
2 Trials on Givosiran: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=Givosiran)